# Lithium

## OVERVIEW

### Introduction

Lithium is a simple alkali metal, the salt of which acts as a mood stabilizing agent which has been extensively used for the treatment of mania for more than 50 years. Lithium has been associated with rare instances of mild serum aminotransferase elevations, but has not been convincingly linked to clinically apparent acute liver injury.

### Background

Lithium (lith' ee um) is the lightest elemental metal and is normally found in low concentrations in human tissue. Lithium salts are highly water soluble and have been used medically for many years. While lithium has no psychotropic effects in normal individuals, it has potent mood stabilizing properties in patients with bipolar disorders, mania and recurrent depression. The mechanism of action of lithium is unknown, but is thought to be mediated by its replacement of sodium ions and disruption of membrane potentials in the central nervous system. It may also act by differential effects on neurotransmitter induced depolarization of membranes or interference with phosphatidylinositol pathways. Lithium was approved for use in bipolar illness in the United States in 1970 and it is still widely used for this indication. Lithium has also been used off-label in therapy of schizophrenia, alcohol dependence, attention deficit disorder and migraine headaches. Lithium is available as capsules or tablets of 150, 300, 450 and 600 mg in generic forms as well in several brand names including Carbolith, Duralith and Eskalith. A typical maintenance dose regimen is 600 to 900 mg daily. Lithium levels are generally monitored because of the narrow therapeutic window between toxicity and effectiveness aiming for levels between 0.6 and 1.2 mEq/L in chronic situations (higher in acute). Common side effects include metallic taste, nausea, tremor, polyuria, polydipsia and weight gain. Uncommon side effects include hypothyroidism. The major serious adverse event is severe lithium toxicity with can include polyuria, hyponatremia, renal disease and encephalopathy. Because of its narrow therapeutic window, lithium requires careful monitoring of drug levels.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in a small proportion of patients on long term therapy with lithium. These abnormalities are usually asymptomatic and transient, reversing even with continuation of medication. Instances of more marked elevations in serum aminotransferases have been reported in patients taking overdoses of lithium, but the other metabolic and systemic effects of lithium overdose generally overshadow hepatic adverse effects. Lithium has not been associated with instances of clinically apparent acute liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lithium causes serum aminotransferase elevations is not known. Some instances of serum aminotransferase elevations occurring on lithium therapy may be due to nonalcoholic fatty liver disease caused by weight gain that occurs in at least one-quarter of treated patients and ranges from 4.5 to 12 kg, generally during the first 1 to 2 years of therapy.

### Outcome and Management

The serum aminotransferase elevations that occur on lithium therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or chronic liver disease have been attributed to lithium.

Drug Class: Antipsychotic Agents, Drugs for Bipolar Disorders, Trace Elements and Metals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lithium – Generic, Carbolith®, Duralith®, Eskalith®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lithium)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lithium Carbonate | 554-13-2 | C-H2-O3.2Li | Lithium Carbonate Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 June 2019

Zimmerman HJ. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-516. (Expert review of hepatotoxicity of psychiatric medications published in 1999; lithium is not discussed).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
McKnelly WV Jr, Tupin JP, Dunn M. Lithium in hazardous circumstances with one case of lithium toxicity. Compr Psychiatry 1970; 11: 279-86. (4 cases of use of lithium in patients with other significant conditions; one patient with heart failure developed jaundice and hepatomegaly attributed to passive congestion rather than lithium). 5443145
Warick LH. Lithium poisoning. Report of a case with neurologic, cardiac and hepatic sequelae. West J Med 1979; 130: 259-63. (36 year old man on high doses of lithium for 10 days developed drowsiness, ataxia, nausea and vomiting with high lithium levels, ALT rising to 911 U/L, Alk P to 178 U/L, normal bilirubin; no follow up on resolution). 425510
Cohen LS, Cohen DE. Lithium-induced hyperbilirubinemia in an adolescent. J Clin Psychopharmacol 1991; 11: 274-5. (17 year old man developed bilirubin elevations after taking lithium for 12 days [rising from 1.4 at baseline to 3.3 mg/dL], while all other tests were normal; authors suspected Gilbert syndrome exacerbated by lithium). 1918429
Kosson H, Chou JC-Y. Abnormal liver function tests associated with lithium treatment. J Clin Psychopharmacol 1992; 12: 216-7. (26 year old man developed mild increases in ALT levels [peak 105 U/L] after 2 months of lithium treatment which decreased on stopping and increased again on restarting on two occasions [from 11 to 56 U/L and 19 to 56 U/L]; no symptoms and no mention of bilirubin elevations or weight gain). 1629393
Smith LA, Cornelius V, Warnock A, Tacchi MJ, Taylor D. Pharmacological interventions for acute bipolar mania: a systematic review of randomized placebo-controlled trials. Bipolar Disorders 2007; 9: 551-60. (Review of 13 short term controlled trials with 3089 patients, weight gain with olanzapine and risperidone, no mention of hepatic adverse events). 17845269
Smith LA, Cornelius V, Warnock A, Bell A, Young AH. Effectiveness of mood stabilizers and antipsychotics in the maintenance phase of bipolar disorder: a systematic review of randomized controlled trials. Bipolar Disord 2007; 9: 394-412. (Review of 14 long term controlled trials of mood stabilizing agents including lithium with 2526 patients, did not evaluate adverse events). 17547586
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand 2008; 118: 4-18. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin, but not with carbamazepine or lamotrigine). 18498432
Young W. Review of lithium effects on brain and blood. Cell Transplant 2009; 18: 951-75. (Review of the mechanism of action of lithium, its clinical uses and toxicity; states that prolonged exposure to high doses of lithium [above 2 mM] can cause liver injury). 19523343
McKnight RF, Adida M, Budge K, Stockton S, Goodwin GM, Geddes JR. Lithium toxicity profile: a systematic review and meta-analysis. Lancet 2012; 379 (9817): 721-8. (A systematic review of the literature on litium toxicity focusing upon renal thyroid and parathyroid function, hair and skin disorders, weight gain and teratogenicity; no mention of hepatic side effects). 22265699
Drugs for psychiatric disorders. Treat Guidel Med Lett 2013; 11 (130): 53-64. (Concise review of the safety and efficacy of drugs for psychiatric disorders states that: "Lithium is generally the drug of choice for maintenace treatment of bipolar disorder"; no mention of hepatic adverse events). 23715100
Drugs for bipolar disorder. Med Lett Drugs Ther 2016; 58 (1501): 103-6. (Concise review of the safety and efficacy of drugs for bipolar disorder; states that "lithium remains the drug of choice for maintenance treatment of bipolar disoder"; no mention of hepatic adverse events). 27508348

## OTHER REFERENCE LINKS

1. Recent References on Lithium: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lithium/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lithium: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lithium)